# Pharmacokinetic Enhancers

## OVERVIEW

Pharmacokinetic enhancers or boosting agents are used in combination with a primary therapeutic agent, not for their direct effects on the disease or condition for which they are used, but because they enhance the activity, increase drug levels and/or prolong the half-life of the primary agent. Pharmacokinetic enhancers typically inhibit enzymes such as human cytochrome P450 (CYP 3A) and thereby block the rate-controlling steps in the metabolism of the primary drug or inhibit its inactivation. While pharmacokinetic enhancers are usually well tolerated, they can be problematic and may account for side effects including liver injury of the drug combination. Furthermore, pharmacokinetic enhancers are often used as a fixed combination with the primary agent in one tablet, capsule, powder or solution for injection. For this reason, their role in causing adverse events may be difficult to define unless there are direct comparisons to subjects treated with the primary agent alone.

Pharmacokinetic enhancers in current use can be categorized into three groups: (1) beta-lactamase inhibitors used in combination with beta-lactam antibiotics such as the penicillins and cephalosporins (clavulanate, tazobactam, sulbactam, avibactam); (2) broad-spectrum inhibitors of hepatic drug-metabolizing enzymes such as CYP 3A4 (ritonavir, cobicistat); and (3) inhibitors of drug-specific metabolizing enzymes (carbidopa, cilastatin, tipiracil). Undoubtedly, other categories of pharmacokinetic enhancers will be developed as they can play an essential role in optimizing pharmacologic and therapeutic effects of important medications.

The major pharmacokinetic enhancers in clinical use in the United States are listed in the table below, along with the primary agent(s) with which they are combined, major brand name(s) of the combination, the enzyme activity that they inhibit or enhance, year of approval, and the hepatotoxicity score of the combination. Specific information and references to their hepatotoxicity are given in the sections on the primary agents rather than separately for the pharmacokinetic enhancer.

PHARMACOKINETIC ENHANCERS (2017)
Pharmacokinetic Enhancer | Primary Agent | Brand Name | Enzyme Inhibited | Year Approved | Likelihood Score†
Carbidopa | Levodopa | Sinemet | L-amino acid decarboxylase | 1975 | E
Clavulanic acid | Amoxicillin | Augmentin | Beta-lactamase | 1984 | A*
Clavulanic acid | Ticarcillin | Timentin | Beta-lactamase | 1985 | A*
Tazobactam | Piperacillin | Zosyn | Beta-lactamase | 1985 | E*
Cilastatin | Imipenem | Primaxin | Dehydropeptidase 1 | 1985 | D
Sulbactam | Ampicillin | Unasyn | Beta-lactamase | 1986 | C
Ritonavir‡ | Lopinavir | Kaletra | CYP 3A4 | 1996 | D
Ritonavir‡ | Paritaprevir | Viekira Pak | CYP 3A4 | 2015 | E*
Cobicistat‡‡ | Elvitegravir | Stribild, Genvoya | CYP 3A4 | 2012 | E
Cobicistat‡‡ | Atazanavir | Evotaz | CYP 3A4 | 2015 | D
Cobicistat‡‡ | Darunavir | Prezcobix | CYP 3A4 | 2015 | E*
Tipiracil | Trifluridine | Lonsurf | Thymidine phosphorylase | 2015 | E
Avibactam | Ceftazidime | Ayvcaz | Beta-lactamase | 2015 | E

† The likelihood score is for the combination, as the role of the primary agent vs the pharmacokinetic enhancer cannot always be clearly demarcated. In the case of clavulanic acid, it is usually considered the primary cause of the liver injury rather than amoxicillin or ticarcillin with which it is combined.

‡ Ritonavir is a HIV-protease inhibitor and has independent activity against HIV infection, but is used commonly to “boost” levels of other drugs active against HIV or HCV that are metabolized by CYP 3A4 and thus achieve higher and more prolonged levels when combined with ritonavir.

‡‡ Cobicistat inhibits several drug-metabolizing enzymes including CYP 3A4, CYP 2D6 and the P-glycoprotein transporter, but has no antiviral activity on its own.

### Pharmacokinetic Enhancers Combined with Specific Primary Agent(s):

Avibactam [Ceftazidime], Carbidopa [Levodopa], Cilastatin [Imipenem], Clavulanic Acid [Amoxicillin, Ticarcillin], Cobicistat [Atazanavir, Darunavir, Elvitegravir], Ritonavir [Lopinavir, Paritaprevir], Sulbactam [Ampicillin], Tazobactam [Piperacillin], Tipiracil [Trifluridine]